# Aminoglycosides

## OVERVIEW

The aminoglycosides are natural products and semisynthetic derivatives from a variety of actinomycetes and have potent activity against many gram negative bacteria. The first aminoglycoside used in clinical practice was streptomycin which was derived from Streptomyces griseus and was the first effective agent against mycobacterium tuberculosis. The discovery and characterization of the antibacterial activity of streptomycin led to the award of the Nobel Prize in Medicine to Selman Waksman and his coworkers. The aminoglycosides have a common structure of two or more amino sugars joined in glycosidic linkage to a hexose nucleus. The aminoglycosides are believed to act by binding to ribosomes of bacteria and blocking protein synthesis.

Aminoglycosides in current use in the United States include streptomycin, gentamicin, tobramycin, amikacin, plazomicin and neomycin. The aminoglycosides are poorly absorbed orally and typically are given parenterally, either by intravenous or intramuscular injection. Gentamicin, tobramycin and amikacin are given parenterally and are used for severe gram negative bacterial infections usually in combination with penicillins or cephalosporins. Streptomycin is now rarely used and largely as adjunctive therapy of multi-drug resistant tuberculosis. Plazomicin is a recently introduced agent and is given intravenously as monotherapy for complicated urinary tract infections or acute pyelonephritis. Plazomicin is a semi-synthetic aminoglycoside which has been modified to evade conventional forms of aminoglycoside resistance. Neomycin is used orally to treat hepatic encephalopathy. Because it is poorly absorbed orally, neomycin causes a decrease in intestinal bacteria, thereby decreasing ammonia production and absorption from the colon.

The aminoglycosides all have serious toxicities which often limit their applicability and the dose and duration of therapy. The common serious adverse effects of the aminoglycosides are ototoxicity, neuropathy and nephrotoxicity. Liver injury from the aminoglycosides is rare, perhaps because the other side effects of aminoglycosides limit the amount that can be given. Isolated case reports of idiosyncratic hepatotoxicity have been published for most, but not all of the aminoglycosides. These resports have not always been very convincing.

Each aminoglycoside is discussed separately while the references for all aminoglycosides (except streptomycin, given in the section on therapy of tuberculosis) are provided below. The following are links to each drug record.

- Amikacin
- Gentamicin
- Neomycin
- Plazomicin
- Streptomycin
- Tobramycin

## ANNOTATED BIBLIOGRAPHY

References updated: 12 April 2019

Zimmerman HJ. Aminoglycosides. Hepatic injury from the treatment of infectious and parasitic diseases. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. p 589. (Expert review of hepatotoxicity of aminoglycosides published in 1999; “few instances of significant hepatic injury have been attributed to agents in this group”).
Moseley RH. Antibacterial and Antifungal Agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd Edition. Amsterdam: Elsevier, 2013. p. 463-81. (Review of hepatotoxicity of antibacterial medications does not discuss the aminoglycosides).
MacDougall C. Aminoglycosides. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1039-48. (Textbook of pharmacology and therapeutics).
Gentry LO. Efficacy and safety of cefamandole plus either gentamicin or tobramycin in therapy of severe gram-negative bacterial infections. J Infect Dis 1978; 137 Suppl: S144-9. (Prospective study in 31 patients given cephalosporin and standard [n=20] or high doses [n=11] of either gentamicin [12] or tobramycin [19]; higher doses were associated with more increases in Alk P [27% vs 5%] and ALT [27% vs 0%], one patient with jaundice had acute hepatitis B). 349093
Mor F, Leibovici L, Cohen O, Wysenbeek AJ. Prospective evaluation of liver function tests in patients treated with aminoglycosides. DICP 1990; 24: 135-7. (Prospective study in 104 patients given gentamicin and 10 given amikacin found no change in ALT, LDH or bilirubin levels, but mild increases in Alk P in 23% of patients; no symptomatic hepatitis). 2309507
Lucena MI, Andrade RJ. [Aminoglycoside nephrotoxicity and obstructive jaundice] Med Clin (Barc) 1995; 105: 457-60. Spanish. (Review of the increased risk of nephrotoxicity in patients with obstructive jaundice). 7490937
Nisly SA, Ray SM, Moye RA. Tobramycin-induced hepatotoxicity. Ann Pharmacother 2007; 41: 2061-5. (Patient with pseudomonas bacteremia treated with multiple antibiotics, developed elevations in AST [970 U/L], ALT [315 U/L] and Alk P [432 U/L] and mild jaundice within days of starting tobramycin; changing antibiotics did not affect enzyme elevations until tobramycin was stopped with resolution in 1-2 weeks; apparently no symptoms or allergic signs). 17956959
Lindblad A, Hultcrantz R, Strandvik B. High doses of aminoglycosides did not produce liver toxicity in patients with cystic fibrosis. J Hepatol 1994; 20: 201-5. (Five patients with cystic fibrosis underwent yearly liver biopsies; those on intermittent aminoglycoside therapy showed no hepatic abnormalities and liver tests were normal in all). 8006400
Nassberger L, DePierre J. High doses of aminoglycoside antibiotics do not induce liver toxicity because uptake is limited. J Hepatol 1994; 21: 1156. (Letter in response to Lindblad et al. postulating that lack of hepatic injury is due to limited uptake of aminoglycosides in the liver compared to kidney and inner ear). 7699252
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 1 case was initially attributed to gentamicin, but later considered unlikely to be related; no other aminoglycoside was listed). 18955056
Wang YP, Shi B, Chen YX, Xu J, Jiang CF, Xie WF. Drug-induced liver disease: an 8-year study of patients from one gastroenterological department. J Dig Dis 2009; 10: 195-200. (30 cases of drug induced liver disease were seen at a single large hospital in Bejing between 2000 and 2007, including one case of cholestatic hepatitis attributed to gentamicin arising 1 day after starting therapy with ALT 2.6 times ULN, Alk P 2.3 times ULN, bilirubin 6.8 mg/dL, with few other details that might separate it from jaundice of sepsis). 19659787
Kwon H, Lee SH, Kim SE, Lee JH, Jee YK, Kang HR, Park BJ, et al. Spontaneously reported hepatic adverse drug events in Korea: multicenter study. J Korean Med Sci 2012; 27: 268-73. (Summary of 2 years of adverse event reporting in Korea; of 9360 reports, 567 were liver related, including 5 attributed to aminoglycosides; no details provided). 22379337
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which, however, were linked to use of aminoglycosides). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 323 [36%] cases were due to antibiotics, but none were attributed to an aminoglycoside antibiotic). 25754159
Connolly LE, Riddle V, Cebrik D, Armstrong ES, Miller LG. A multicenter, randomized, double-blind, phase 2 study of the efficacy and safety of plazomicin compared with levofloxacin in the treatment of complicated urinary tract infection and acute pyelonephritis. Antimicrob Agents Chemother 2018; 62 (4). (Among 145 patients with complicated urinary tract infections or pyelonephritis treated with intravenous plazomicin [10 or 15 mg/kg] or levofloxacin [750 mg] once daily for 5 days, microbiological response rates were similar in all 3 groups, but adverse event rates were less with plazomicin and there were no instances of clinically apparent liver injury with jaundice). 29378708
Shaeer KM, Zmarlicka MT, Chahine EB, Piccicacco N, Cho JC. Plazomicin, a next-generation aminoglycoside. Pharmacotherapy 2019; 39: 77-93. (Review of the chemistry, pharmacology, clinical efficacy and safety of plazomicin; mentions that nephrotoxicity and ototoxicity are rare; no discussion of ALT elevations or hepatotoxicity). 30511766
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy; mentions that ALT elevations during plazomicin therapy occurred in 0.3% or less of treated subjects, rates that were similar to those of comparator agents).

## OTHER REFERENCE LINKS

1. Recent References on Aminoglycosides: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=aminoglycosides/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%222005/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Aminoglycosides: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=aminoglycosides)